# Perindopril

## OVERVIEW

### Introduction

Perindopril is an angiotensin-converting enzyme (ACE) inhibitor used in the therapy of hypertension and stable coronary artery disease. Perindopril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Perindopril (per in' doe pril) is an ACE inhibitor which is approved for use alone and in combination with other agents in the therapy of hypertension. Like other ACE inhibitors, perindopril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other host enzymes besides that which converts angiotensin I to II may be inhibited as well, which may account for some of the side effects of the ACE inhibitors. Perindopril was approved for use in the United States in 1993, and current indications are for therapy of hypertension and to reduce the risk of cardiovascular mortality in patients with stable coronary artery disease. Perindopril is available in 2, 4 and 8 mg tablets in generic forms and under the trade name Aceon. The typical daily dose in adults is 4 to 8 mg in one or two divided doses, which is administered long term. Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Perindopril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was similar to the rate with placebo therapy. These elevations were transient and rarely required dose modification. Instances of jaundice and hepatic injury are listed as potential side effects of perindopril in the product label; however, clinically apparent cases of acute liver injury due to perindopril have yet to be reported in the published literature. Other ACE inhibitors have been associated with rare instances of clinically apparent liver injury, which typically arises 2 to 12 weeks after starting therapy and is associated with a cholestatic pattern of injury which can be severe and prolonged. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. In addition, rare instances of severe acute hepatocellular injury, sometimes arising 1 to 4 years after starting therapy, have been linked to selected ACE inhibitors, but not specifically to perindopril. Nevertheless, the product label mentions the possibiltiy of drug induced liver injury.

Likelihood score: E* (unproved but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated ACE inhibitors including perindopril is not known. Perindopril is hydrolyzed in the liver to the active metabolite perindoprilat, but undergoes minimal further hepatic metabolism. Idiosyncratic liver injury due to the ACE inhibitors is likely due to a reaction to a minor metabolite.

### Outcome and Management

There have been too few instances of perindopril associated liver injury described to provide an overall description of its course and outcome. Most instances of acute liver injury reported with ACE inhibitors have been self limited, but there have been rare reports of acute liver failure due to captopril, enalapril, lisinopril and benazepril and several reports of cholestatic hepatitis due to ACE inhibitors leading to prolonged jaundice and vanishing bile duct syndrome. Patients with severe perindopril induced acute liver injury should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of perindopril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Perindopril – Generic, Aceon®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Perindopril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Perindopril | 82834-16-0 | C19-H32-N2-O5 | Perindopril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Perindopril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Perindopril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Perindopril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Perindopril)